# LiverTox – Editors and External Expert Review Committee

## Senior Editor

Jay H. Hoofnagle, M.D. is the senior editor and primary author of LiverTox, responsible for researching the scientific literature, writing drug chapters with overview of drug induced liver injury. Dr. Hoofnagle is a graduate of Yale Medical School and did post-graduate training in internal medicine, gastroenterology, and hepatology. He has been a senior investigator in liver disease in the National Institute of Diabetes and Digestive and Kidney Diseases (NIDDK) of the National Institutes of Health (NIH) for more than 40 years and is currently Director of the Liver Disease Research Branch, Division of Digestive Diseases and Nutrition, NIDDK. In that capacity, he administers a portfolio of basic and clinical research grants that examine the cause, natural course, prevention, and treatment of liver diseases. He also oversees clinical research networks such as the Liver Cirrhosis Network, the NASH Clinical Research Network, and the Drug-Induced Liver Injury Network. Dr. Hoofnagle is a former president of the American Association for Liver Disease and is a recipient of the Association’s Distinguished Achievement Award. He is the author of more than 500 articles in the medical literature and has conducted both clinical and basic research on liver diseases including hepatitis A, B, C, D and E as well as acute liver failure, nonalcoholic steatohepatitis, autoimmune liver diseases, biliary atresia and drug induced liver disease.

## Deputy Editor

James E. Knoben, Pharm. D., M.P.H. is the deputy editor of LiverTox, and he provides expertise in drug classification and ensures integrity of the data within LiverTox. Dr. Knoben is a graduate of the University of California and holds an M.P.H. degree from Yale University Medical School. He has extensive experience in biomedical writing, including serving 30 years as co-editor of a drug information handbook that was utilized worldwide in clinical education and practice. He served 12 years as director of the Division of Drug Information Resources in the Food and Drug Administration, and more recently as drug information consultant to the National Library of Medicine, NIH.

## Administrator

Ms. Marge Worrest is the administrator in support of LiverTox. Ms. Worrest is a graduate of Keystone College and has served in program management positions for several government agencies, including the Department of Defense in Strategic Planning, Budget and Program Finance, and the Department of Homeland Security in Program Budget and Mission Support-Reimbursable Programs and is a Certified Greenbelt in Six Sigma Lean practices. Ms. Worrest is responsible for developing schedules of updating, editing and outside review of the LiverTox website. She is responsible for the management of the External Expert Review Committee and the flow of the Committee’s reviews and updates of LiverTox.

## External Expert Review Committee

The LiverTox External Expert Review Committee is comprised of three non-federal experts in drug induced liver injury, hepatology, pharmacology and/or herbal supplement safety. The members are appointed by the NIDDK and serve 3-year, renewable terms. The review committee provides oversight of the LiverTox database with respect to assessing new content and revisions/updates of current content; advising on improvements to the accuracy, format, reliability, and usefulness of the site; and advising on policies governing the LiverTox website. The Expert Review Committee is also responsible for ensuring accurate peer review of all new material added to LiverTox. Currently, the review committee consists of the following individuals:

Adrian M. Di Bisceglie, M.D. received his medical degree from the University of Witwatersrand, Johannesburg, South Africa and completed his training in Internal Medicine at Baragwanath Hospital, Johannesburg before doing a research fellowship at the National Institutes of Health (NIH) where he went on to become chief of the Liver Diseases Section, NIDDK. He is currently a Professor of Internal Medicine at Saint Louis University where he served as department chairman from 2006 to 2017. Dr. Di Bisceglie served on the governing board of the American Association for the Study of Liver Disease (AASLD) and was President of that organization in 2014. He has served on the editorial boards of many journals including Hepatology, Liver Transplantation and as Section Editor on Hepatitis C for UpToDate. Dr. Di Bisceglie has received numerous awards including the AASLD Distinguished Service Award and Outstanding St. Louis Scientist Award from the Academy of Science of St. Louis.

Herbert L. Bonkovsky, M.D. is Professor of Medicine and Molecular Medicine & Translational Research, and Director of the Liver and Metabolic Disorders Laboratory at Wake Forest University/NC Baptist Medical Center. He is a graduate of Case Western Reserve Medical School and did post-graduate training at Duke University, the National Institutes of Health and Dartmouth Medical School, and Liver and Gastroenterology fellowship training at Yale Medical School. He is board certified in internal medicine and gastroenterology. His research interests have been in porphyrin and heme metabolism, the effects of heme and iron on gene expression and intermediary metabolism and in drug and herbal induced liver injury.

Lily Dara, M.D. is an NIH-funded physician-scientist at the University of Southern California with a research interest in drug-induced liver injury and immune-mediated liver diseases. She is a graduate of Shahid Beheshti University of Medical Sciences in Tehran, Iran and completed an Internal Medicine Residency at Griffin Hospital, a Yale-affiliated program in Connecticut and Gastroenterology Fellowship at the University of Southern California in Los Angeles. She has served on the editorial boards of both Hepatology and Gastroenterology and is currently Vice Chair of the AASLD Hepatotoxicity SIG.

Dina Halegoua-De Marzio, M.D. is a transplant hepatologist and associate professor of medicine at Sidney Kimmel Medical College at Thomas Jefferson University (TJU). She completed her residency in internal medicine and fellowships in gastroenterology and transplant hepatology at TJU hospital. She developed the first adult Fatty Liver Center in the Delaware Valley and currently serves as its director. She also serves as the director of gastrointestinal research at TJU and is the associate chief for the Division of Gastroenterology and Hepatology. She been recognized “Teacher of the Year” for her specialty at TJU hospital and was placed on the Sidney Kimmel Medical College Education Honor Roll as an excellent educator. Her main areas of focus include nonalcoholic fatty liver disease and drug-induced liver injury. Her research has been presented internationally and published in numerous medical journals.

James H. Lewis, M.D., FAASLD, AGAF, FACG, FACP is Professor of Medicine on the Clinician-Scholar track of Georgetown University School of Medicine, Washington, DC, and Director of Hepatology in the Division of Gastroenterology, Med-Star Georgetown University Hospital, Washington, DC. A 1971 graduate of Oberlin College, he received his M.D. degree in 1975 from the State University of New York. Following a medical internship at Baylor College of Medicine and residency at Kings County Hospital-Downstate Medical Center in Brooklyn, NY, he completed his gastroenterology (GI) fellowship training (1978-1980) at George Washington University Medical Center in Washington, DC, where he remained on the faculty until 1985, under the mentorship of Hyman J. Zimmerman, M.D., with whom he worked for nearly 20 years in the field of drug-induced liver injury. He has held his present post at Georgetown University Medical Center since 1985, with a one year “sabbatical” to work at Glaxo Pharmaceuticals in drug development and medical affairs. He is a former voting member of the FDA GI Drugs Advisory Committee (1986-1990) and has served as a consultant hepatologist to the FDA. He remains an active consultant to the pharmaceutical industry in drug development and hepatic safety issues. He is the author of more than 450 journal articles, book chapters and abstracts, and the editor of three books. His principal clinical research interests are drug-induced liver disease and chronic viral hepatitis. He is the current Academic Lead for the IQ DILI Network.

External Review Committee Members, Years of Service

Herbert L. Bonkovsky, M.D. – 2019-present

Lily Dara, M.D. – 2023-present

Adrian M. Di Bisceglie, M.D. – 2019-present

Dina Halegoua-De Marzio, M.D. – 2024-present

James H. Lewis, M.D., FAASLD, AGAF, FACG, FACP – 2024-present

Raj Vuppalanchi, M.D. – 2019-2022

## Ad Hoc Members of the External Expert Review Committee

The expert review committee may include ad hoc members, including other experts in drug induced liver injury from NIDDK and other NIH Institutes such as the National Library of Medicine and Office of Dietary Supplements as well as from the Food and Drug Administration and other Federal Agencies. The composition of the committee is subject to change as the database evolves.

Mark Avigan, M.D., CM is Associate Director for Critical Path Initiatives in the Office of Pharmacovigilance and Epidemiology at the Food and Drug Administration. As a clinical hepatologist with expertise in drug safety science, he served as a division director at FDA in drug safety from 2003 to 2011 and more recently as a consultant within the agency for the evaluation of drug-induced liver injury during the life cycle of drugs and biological agents. Dr. Avigan was a faculty member at the Georgetown University Medical Center until 1999 and was the principal investigator of NIH-funded grants in cell growth regulation. He is a long-standing member of the Drug Safety Oversight Board at the FDA’s Center for Drug Evaluation and Research and continues to have an active role in public-private partnerships that support the scientific and clinical analysis of hepatotoxicity.

Averell H. Sherker, M.D., FRCPC, FAASLD is Scientific Advisor for Viral Hepatitis and Liver Diseases in the NIDDK, NIH. He provides scientific guidance to the Division of Digestive Diseases and Nutrition as it focuses and accelerates research on liver disease at the NIDDK. He oversees a portfolio of research grants related to liver disease, including several clinical research networks. He acts as Program Official for the Drug-Induced Liver Injury Network. He received his MD from Queen’s University in Kingston, Canada and trained in medicine, gastroenterology, and hepatology at University of Toronto. He has molecular virology training from Stanford University and Chiba University, Japan. Previously, he was director of hepatology research at McGill University and subsequently was director of the Center for Liver Diseases at the Washington Hospital Center and attending physician and associate professor at Georgetown University School of Medicine.

Christopher Koh, M.D., MHSc, FACP, FAASLD is the Clinical Director for the Division of Intramural Research in the National Institute of Diabetes and Digestive and Kidney Diseases (NIDDK) of the National Institutes of Health (NIH) and serves as investigator with the Liver Diseases Branch, NIDDK, NIH. As a clinical investigator, he has extensive experience in studying novel therapeutics in viral hepatitis, clinical biomarkers in liver disease, liver disease in rare populations, and drug induced liver injury. He also serves as the principal investigator for the NIH Clinical Center in the Drug Induced Liver Injury Network.

Paul H. Hayashi, M.D., MPH received his medical degree at the University of California (UC) San Diego and Master of Public Health at Saint Louis University. He completed fellowships at UC Davis, the National Institutes of Health, and University of Colorado. He is board certified in gastroenterology and transplant hepatology. He was Professor of Medicine and Medical Director of Liver Transplantation at the University of North Carolina (UNC) in Chapel Hill prior to joining the FDA in 2020 as a Medical Officer in the Center for Drug Evaluation and Research. While at UNC, he cared for patients across the spectrum of liver disorders including hepatotoxicity. He also served as Co-principal Investigator and Co-Chair of the Causality Committee for the Drug-Induced Liver Injury Network.

David Kleiner, M.D., Ph.D. is a graduate of the University of Chicago Medical School and earned a Ph.D. in Chemistry from the same institution. After a residency in Anatomic Pathology at the National Cancer Institute (NCI), he joined the faculty of the NCI’s Laboratory of Pathology. He is currently a Senior Research Physician and Chief of the Postmortem Section of the Laboratory of Pathology with expertise in hepatic pathology. His research has focused on chronic liver disease, with particular attention to assessing histological responses to therapy. Since 2005 he has served as the central pathologist for the Drug Induced Liver Disease Network of the National Institute of Diabetes and Digestive and Kidney Disease. He has authored over 400 articles in the medical literature and is the author of multiple book chapters and review articles on the histopathology of drug-induced liver injury.

Marc Ghany, M.D., M.H.Sc. is a Gastroenterologist and Investigator at the Liver Diseases Branch of the National Institute of Diabetes and Digestive and Kidney Diseases at the Clinical Center of the National Institutes of Health, Bethesda, Maryland. He started in the Liver Diseases Branch, NIDDK in 1996 as a Medical Staff Fellow and was made a Staff Physician in 2000 and promoted to a tenured Senior Investigator in 2022. His main areas of scientific focus include clinical research in liver disease and cirrhosis and the virology, epidemiology, and therapy of chronic viral hepatitis B and C. Dr. Ghany received his medical degree from the Royal College of Surgeons in Dublin, Ireland, completed his residency in Internal Medicine at St. Raphael’s Hospital in New Haven, a Yale-affiliated residency program, and finished a fellowship in Gastroenterology at Tulane University. From 1995-1996, he was a Clinical Instructor in the Department of Medicine, Section of Gastroenterology and Hepatology of Tulane University. He is board certified in Gastroenterology and Internal Medicine and has published over 200 original articles, editorials, and reviews on liver disease.

Martha C. Garcia, Ph.D. is a scientist with expertise on drug metabolism and liver toxicity. As a Program Officer in the Division of Digestive Diseases and Nutrition (NIDDK), she administers a basic and translational research portfolio in the areas of drug-induced liver injury and fatty liver disease.

Steven Casper, Ph.D. is a reviewer in the Office of Dietary Supplement Programs (ODSP) at CFSAN, FDA, College Park, Maryland. He reviews botanical dietary supplement ingredients in new dietary ingredient notifications submitted to ODSP and, as an Ethnobotanist, serves as a botany expert for FDA.

Frank A. Anania, M.D. is the Deputy Director of the Division of Hepatology and Nutrition (DHN) in the Office of New Drugs (OND) in CDER, FDA. He has extensive clinical and research experience related to Hepatology and helps to oversee reviews of drugs related to non-malignant, non-infectious liver diseases, including non-alcoholic steatohepatitis (NASH)/metabolic-associated dysfunction steatohepatitis (MASH).

Special Ad Hoc Reviewers

Special ad hoc reviewers of content of LiverTox include specialists in nutrition, gastroenterology and hepatology from the intramural divisions at the Clinical Center of the National Institutes of Health. These include:

Gracia Viana Rodriguez, M.D. (Liver Diseases Branch, Intramural Division, NIDDK, NIH)

Milica Chernick, M.D. (Cystic Fibrosis Section, Intramural Division, NIDDK, NIH)

Maria Mironova, M.D. ( Liver Diseases Branch, Intramural Division, NIDDK, NIH)

Alla Turshudzhyan, M.D. (Liver Diseases Branch, Intramural Division, NIDDK, NIH)

Special Outside Reviewers

Special outside reviewers of content of LiverTox include experts on hepatotoxicity, pharmacology, herbal medicine, dietary supplements, and medical specialties such as cardiology, oncology, infectious diseases, neurology, gynecology and endocrinology. These include: Victor Navarro, M.D. [Thomas Jefferson University Hospital, Philadelphia, PA]; William Lee, M.D. [University of Texas, Southwestern, Dallas, TX]; Nazia Qazi, M.D. [Southshore University Hospital, Northwell Health Bayshore, NY]; Dwight Montgomery Bissell, M.D. [University of California, San Francisco, CA]; Andrew Stolz, M.D. [LAC University of Southern California Specialty Clinic, Los Angeles, CA]; Naga Chalasani, M.D. [Indiana University Health Physicians Gastroenterology, Indianapolis, Indiana]; A. Sidney Barritt IV, M.D. [The University of North Carolina at Chapel Hill, NC]; Craig Lammert, M.D. [Indiana University Health Physicians Digestive & Liver Disorders, Indianapolis, Indiana]; Robert Fontana, M.D., [University of Michigan Health System, Ann Arbor, MI], Gina Choi, M.D., [David Geffen School of Medicine at UCLA, Los Angeles, CA], Einar S. Bjornsson, M.D., Ph.D., [Landspítali - The National University Hospital of Iceland].

Editorial Support

Editorial and informatics support is provided by the National Center for Biotechnology Information, National Library of Medicine, NIH, which hosts the LiverTox website in Bookshelf, a site that provides access to books and documents in healthcare and life science.